# Deuruxolitinib

## OVERVIEW

### Introduction

Deuruxolitinib is an orally available small molecule inhibitor of Janus kinases that is used to treat severe alopecia areata. Deuruxolitinib is associated with a low rate of transient and usually mild elevations in serum aminotransferase levels during therapy but has not been linked to cases of clinically apparent acute liver injury.

### Background

Deuruxolitinib (dew rux” oh li’ ti nib) is an orally available, specific inhibitor of Janus-associated kinases (greater inhibition of JAK1, JAK2, and TYK2 relative to JAK3) that is used to treat moderate-to-severe alopecia areata. Alopecia areata is an autoimmune disorder that is characterized by hair loss resulting in patches and even complete baldness of the scalp, along with thinning or loss of eyebrows and eyelashes. It is believed to be an autoimmune condition. The Janus kinases are critical steps in immune activation that transmit signals for different cytokine receptors and promote expression of genes involved in production of proinflammatory cytokines. Inhibitors of JAK kinases have been used to treat several autoimmune diseases including alopecia areata. In two large randomized controlled trials, deuruxolitinib was found to decrease or reverse hair loss in adults with alopecia areata. Deuruxolitinib was approved for this use in the United States in 2024, the third small molecule JAK inhibitor approved as therapy for alopecia areata, after baricitinib (in 2022) and ritlecitinib (in 2023). Deuruxolitinib is available in tablets of 8 mg under the brand name Leqselvi. The recommended dose is 8 mg twice daily. Current indications are severe alopecia areata (as defined by 50% hair loss or greater) in adults. Common side effects are headache, acne, rash, nasopharyngitis, fatigue, weight gain, skin and soft tissue infections, and herpes virus reactivation. Deuruxolitinib can also cause anemia, lymphopenia, neutropenia, thrombocytopenia, hyperlipidemia, and creatine kinase elevations. Potential severe adverse events may include reactivation of fungal, viral, and opportunistic infections such as tuberculosis, hepatitis B, herpes simplex, and herpes zoster. Other JAK inhibitors have been linked to a higher rate of all-cause mortality and rarely to venous and arterial thromboses and to malignancies and major atherosclerotic cardiovascular and cerebrovascular events (myocardial infarction, stroke, and cardiovascular death).

### Hepatotoxicity

In the prelicensure clinical trials in alopecia areata, serum aminotransferase elevations occurred in less than 1% of deuruxolitinib-treated subjects and there were no instances of ALT or AST elevations accompanied by symptoms or jaundice. The elevations were typically mild and transient and did not lead to dose adjustments or discontinuations. In prelicensure studies in alopecia areata, there were no instances of liver related severe adverse events or drug induced liver injury. Since approval of deuruxolitinib, there have been no published reports of hepatotoxicity associated with its use, but clinical experience with it has been limited.

Finally, deuruxolitinib is an immune modulatory agent and has the potential of causing reactivation of viral infections including hepatitis B. Other JAK inhibitors have been implicated in rare instances of reactivation of hepatitis B, although the episodes were usually asymptomatic and self-limited in course. The risk of reactivation of hepatitis B in patients with HBsAg or with anti-HBc without HBsAg who are treated with deuruxolitinib has not been defined as patients with these viral markers were excluded from the preregistration trials.

Likelihood score: E* (unlikely cause of idiosyncratic clinically apparent liver injury but is a potential cause of reactivation of hepatitis B).

### Mechanism of Injury

The mechanism by which deuruxolitinib might cause liver injury is not known. It is metabolized in the liver, largely via CYP 2C9 and to a lesser extent by 3A4. High levels can arise in patients who are slow metabolizers by CYP 2C9 and the product label recommends testing patients for CYP 2C9 metabolized status before its use. Furthermore, coadministration of deuruxolitinib with moderate or strong inhibitors of CYP 2C9 can lead to marked elevations in plasma levels and such agents should not be used. Finally, concurrent use of inducers of CPY 2C9 or 3A4 can lead to lower plasma levels and possible loss of effect and should not be avoided. The pharmacokinetics of deuruxolitinib are not affected by mild-to-moderate liver impairment (Child-Pugh A or B), but its use is not recommended in patients with severe impairment (Child-Pugh C).

### Outcome and Management

Serum aminotransferase elevations are uncommon during deuruxolitinib therapy, and routine monitoring of liver tests is not recommended in the product label. If aminotransferase elevations above 5 times the upper limit of normal (ULN) arise, deuruxolitinib therapy should be interrupted, at least temporarily, until levels fall into the normal or near normal range. Elevations above 20 times the ULN or any elevations accompanied by symptoms or jaundice should lead to permanent discontinuation.

Because of its potential to cause reactivation of hepatitis B, routine blood screening for HBsAg and anti-HBc before starting therapy with deuruxolitinib is appropriate. Patients with HBsAg in serum should be treated prophylactically during therapy using an oral antiviral agent with activity against HBV such as entecavir or tenofovir. An alternative approach, which is also appropriate for patients with anti-HBc without HBsAg, is to monitor patients carefully for HBV DNA and initiate antiviral therapy if HBV DNA becomes detectable in serum.

Drug Class: Dermatologic Agents, Protein Kinase Inhibitors

Other Drugs for Alopecia areata: Baricitinib, Ritlecitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Deuruxolitinib – Leqselvi®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Deuruxolitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Deuruxolitinib | 1513883-39-0 | C17-H18-N6

## ANNOTATED BIBLIOGRAPHY

References updated: 07 November 2024

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as baricitinib and deuruxolitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not the JAK inhibitors such as deuruxolitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; deuruxolitinib is not discussed).
FDA. Multi-Discipline Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217900Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy mentions that the rate of liver enzyme elevations during deuruxolitinib therapy was low [less than 1%] and among more than 1000 patients exposed to deuruxolitinib there were no serious hepatic adverse events and no instances of drug-induced liver injury).
Hoisnard L, Lebrun-Vignes B, Maury S, Mahevas M, El Karoui K, Roy L, Zarour A, et al. Adverse events associated with JAK inhibitors in 126,815 reports from the WHO pharmacovigilance database. Sci Rep. 2022;12:7140. (Among 126,815 individual case safety reports on ruxolitinib, tofacitinib and baricitinib made to the WHO pharmacovigilance registry, infections were most frequent including viral, fungal, bacterial, and mycobacterial complications while there was no increase in hepatobiliary reports). 35504889
King B, Ohyama M, Kwon O, Zlotogorski A, Ko J, Mesinkovska NA, Hordinsky M, et al.; BRAVE-AA Investigators. Two phase 3 trials of baricitinib for alopecia areata. N Engl J Med. 2022;386:1687-1699. (Among 1200 patients with alopecia areata treated with baricitinib or placebo once daily for 36 weeks in two controlled trials, clinical responses were higher with 4 mg [39% and 36%] than with 2 mg [23% and 19%] or placebo [6.2% and 3.3%], while adverse event rates were similar in all 3 groups, and ALT elevations above 3 times ULN were less frequent with baricitinib than placebo [1.5% vs 2.7%]). 35334197
Shawky AM, Almalki FA, Abdalla AN, Abdelazeem AH, Gouda AM. A comprehensive overview of globally approved JAK inhibitors. Pharmaceutics. 2022;14:1001. (Review of the JAK-STAT pathways and currently approved JAK inhibitors; JAK proteins are cytoplasmic, non-receptor tyrosine kinases involved in transduction of cytokine signals that pair when binding to transmembrane cytokine receptors and, once activated, phosphorylate STAT causing its dimerization and transfer to the nucleus where it activates cytokine induced genes). 35631587
King B, Guttman-Yassky E, Peeva E, Banerjee A, Sinclair R, Pavel AB, Zhu L, et al. A phase 2a randomized, placebo-controlled study to evaluate the efficacy and safety of the oral Janus kinase inhibitors deuruxolitinib and brepocitinib in alopecia areata: 24-week results. J Am Acad Dermatol. 2021;85:379-387. (Among 142 patients with alopecia areata treated with ritlecitinib or brepocitinib or placebo for 24 weeks, the alopecia severity scores improved more with the JAK inhibitors [31% and 49% vs 2%], while adverse event rates were similar in all three groups [67% and 77% vs 74%] and there were no elevations in serum ALT or AST above 2.5 times ULN in patients receiving ritlecitinib). 33757798
Papierzewska M, Waśkiel-Burnat A, Rudnicka L. Safety of Janus kinase inhibitors in patients with alopecia areata: a systematic review. Clin Drug Investig. 2023;43:325-334. (Review of the safety and adverse events associated with the small molecule JAK inhibitors used to treat alopecia areata mentions that “elevated liver enzymes” arose in 5.2% of patients on ruxolitinib, 2.7% on tofacitinib, but does not provide information on deuruxolitinib). 37138134
King BA, Craiglow BG. Janus kinase inhibitors for alopecia areata. J Am Acad Dermatol. 2023;89:S29-S32. (Brief review of the mechanism of action, clinical efficacy, and safety of the three JAK inhibitors approved for use for alopecia areata – baricitinib, ritlecitinib, and deuruxolitinib – concludes that their efficacy is not very different and failure of one does not preclude failure of another JAK inhibitor; no mention of ALT elevations during therapy or hepatotoxicity). 37591562
King B, Senna MM, Mesinkovska NA, Lynde C, Zirwas M, Maari C, Prajapati VH, et al. Efficacy and safety of deuruxolitinib, an oral selective Janus kinase inhibitor, in adults with alopecia areata: Results from the Phase 3 randomized, controlled trial (THRIVE-AA1). J Am Acad Dermatol. 2024;91:880-888. (Among 706 adults with severe alopecia areata treated with deuruxolitinib [8 or 12 mg] or placebo twice daily for 24 weeks, clinical response rates were 30% and 41.5% with deuruxolitinib vs 0.8% with placebo, while adverse event rates were 65% and 64% vs 56% which were serious in 1.1% and 0.5% vs 2.9%, and there were no serious hepatic adverse events; no mention of ALT elevations or hepatoxicity). 39053611

## OTHER REFERENCE LINKS

1. Recent References on Deuruxolitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Deuruxolitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Deuruxolitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Deuruxolitinib)